# Diflunisal

## OVERVIEW

### Introduction

Diflunisal is a salicylic acid derivative that is used in the therapy of chronic arthritis and mild to moderate acute pain. Diflunisal has been linked mild, transient elevations in serum aminotransferase levels during therapy as well as to rare instances of idiosyncratic drug induced liver disease.

### Background

Diflunisal (dye floo' ni sal) is a difluorophenol derivative of salicylic acid that has antiinflammatory, analgesic and antipyretic actions similar to aspirin. Diflunisal is metabolized by the liver, but not to salicylate. Diflunisal is considered a nonsteroidal antiinflammatory agent (NSAID) and is believed to act by inhibition of tissue cyclo-oxygenases (Cox-1 and Cox-2), which leads to a decrease in synthesis of proinflammatory prostaglandins, important mediators in inflammatory and pain pathways. Diflunisal was approved for use in the United States in 1982 and current indications are for chronic arthritis due to osteoarthritis or rheumatoid arthritis and for mild-to-moderate pain. Diflunisal has been shown to stabilize transthyretin variants which are involved in the pathogenesis of amyloidosis, which has led to the off-label use of diflunisal in familial amyloidosis. Diflunisal is available as tablets of 500 mg in generic forms and formerly under the brand name of Dolobid. Diflunisal is available by prescription only. The recommended regimen in adults is an initial dose of 1000 mg, followed by 500 to 1500 mg daily in two to three divided doses based upon response and tolerance. Diflunisal, like most NSAIDs, is generally well tolerated, but side effects can include intestinal upset, nausea, heartburn, headache, somnolence, dizziness, peripheral edema and hypersensitivity reactions.

### Hepatotoxicity

Diflunisal therapy is reported to be associated with a low rate of asymptomatic and transient serum aminotransferase elevations, which may resolve even with drug continuation. Marked aminotransferase elevations (>3 fold elevated) occur rarely. Clinically apparent liver injury with jaundice from diflunisal is uncommon; only case reports have been published. The clinical and histologic features of diflunisal hepatotoxicity, however, are distinct and resemble an immunoallergic hepatitis, which is quite different from the liver injury that occurs with aspirin or other salicylates (Case 1). The latency to onset ranges from 1 to 4 weeks and the pattern of enzyme elevations is typically cholestatic, but can also be mixed. Most patients have immunoallergic manifestations such as rash, fever and arthralgias; eosinophilia or atypical lymphocytosis are also common. A history of aspirin allergy has not been reported among cases with allergic reactions to diflunisal. Diflunisal is not a commonly used drug and is not mentioned in large case series on drug induced liver injury or acute liver failure.

Likelihood score: C (probable cause of clinically apparent liver injury).

### Mechanism of Liver Injury

The mechanism of diflunisal hepatotoxicity is likely hypersensitivity and is different from that of acetylsalicylic acid (aspirin).

### Outcome and Management

Severity ranges from asymptomatic elevations in serum aminotransferase levels, to symptomatic cholestatic hepatitis with or without jaundice. It is not clear if there is cross sensitivity to liver injury between diflunisal and other salicylates.

Drug Class: Salicylates, Nonsteroidal Antiinflammatory Drugs

## CASE REPORT

### Case 1. Cholestatic jaundice arising after a few days of diflunisal therapy.(1)

A 65 year old woman with venous stasis ulcers was given diflunisal (750 mg daily) for leg pain while being treated with intravenous penicillin for suspected cellulitis. When therapy was started, serum enzymes and bilirubin levels were normal (Table). Diflunisal was stopped after 3 days because of gastrointestinal intolerance. Five days later, blood tests showed marked elevations of alkaline phosphatase with mild hyperbilirubinemia. There was eosinophilia but no rash, lymphadenopathy or further fever. She had had a cholecystectomy in the past, but no history of liver disease or risk factors for viral hepatitis were mentioned. Ultrasound of the abdomen and endoscopic retrograde cholangiopancreatography were unrevealing. A liver biopsy showed portal inflammation with eosinophils and lobular histiocytic granulomas. Over the next weeks, laboratory test abnormalities fell toward normal despite continuation of penicillin and her medications for depression (clorazepate and viloxazine). Four months later all blood test results were normal.

#### Key Points

Medication: | Diflunisal (750 mg daily for 3 days)
Pattern: | Cholestatic (R=0.3)
Severity: | 3+ (jaundice and prolongation of hospitalization)
Latency: | 3 days to symptoms, 8 days to detection of jaundice
Recovery: | 2-4 months
Other medications: | Penicillin (iv), clorazepate, viloxazine

#### Laboratory Values

Time After Starting | Time After Stopping | AST (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Comments
1 day | 0 | 13 | 80 | 0.3 | eosinophils 2%
8 days | 5 days | 60 | 1216 | 2.6 | eosinophils 12%
13 days | 10 days | 50 | 1474 | 1 | Liver biopsy
30 days | 27 days | 16 | 672 | 0.6 | eosinophils 34%
2 months | 2 months | 19 | 193 | 0.3 | eosinophils 23%
5 months | 5 months | 18 | 70 | 0.2 | eosinophils 3%
Normal Values | | Not given

#### Comment

Despite absence of some clinical information, this is a convincing case of cholestatic jaundice caused by diflunisal. As in other cases, the latency was quite short and there was at least some evidence for an immunoallergic reaction (eosinophilia). Granulomas found on liver biopsy do not indicate “granulomatous hepatitis”, but are rather further evidence of a generalized immunoallergic reaction. The rapid clinical recovery (1 month), but delayed fall of alkaline phosphatase to the normal range (between 2 and 5 months) is typical of cholestatic drug induced liver injury.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Diflunisal – Generic

DRUG CLASS

Antiinflammatory Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=diflunisal)

Product labeling at DailyMed, National Library of Medicine, NIH.

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Diflunisal | 22494-42-4 | C13-H8-F2-O3

## CITED REFERENCE

1 Geoffroy P, Carteret E, Salagnac V, Kalis B, Zeitoun P. (1987). Therapie.

## ANNOTATED BIBLIOGRAPHY

References updated: 03 January 2018

Zimmerman HJ. Drugs used to treat rheumatic and musculospastic disease. Chapter 19: The NSAIDS. In Zimmerman, HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott Williams & Williams, 1999, pp. 517-41. (Review of hepatotoxicity of NSAIDs published in 1999).
Lewis JH, Stine JG. Nonsteroidal anti-inflammatory drugs and leukotriene receptor antagonists. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 369-402. (Expert review of liver injury caused by NSAIDs mentions that diflunisal is a difluorophenol derivative of salicylate and can cause cholestatic injury but that there have been few published reports).
Grosser T, Smyth E, FitzGerald GA. Anti-inflammatory, antipyretic, and analgesic agents; pharmacotherapy of gout. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 959-1004. (Textbook of pharmacology and therapeutics).
Warren JS. (1978). Diflunisal-induced cholestatic jaundice. Br Med J. (64 year old man who was previously treated with multiple NSAIDs without relief was placed on diflunisal [while also receiving indomethacin] and developed itching 5 days later [bilirubin 3.4 mg/dL, AST 120 U/L, Alk P 780 U/L] without eosinophilia, rash or fever, and resolving within 2 months of stopping).
Brogden RN, Heel RC, Pakes GE, Speight TM, Avery GS. (1980). Diflunisal: a review of its pharmacological properties and therapeutic use in pain and musculoskeletal strains and sprains and pain in osteoarthritis. Drugs. (Review of pharmacology, pharmacokinetics, clinical efficacy and safety of diflunisal; "no consistent alteration in tests of renal or liver function have been reported").
Umbenhauer ER. (1983). Diflunisal in the treatment of the pain of osteoarthritis. Summary of clinical studies. Pharmacotherapy. (Review of results of 5 controlled studies of diflunisal vs aspirin or ibuprofen or placebo in 1218 patients; side effects were more frequent with aspirin and ibuprofen than diflunisal but discontinuations for AST elevations occurred in 0.9% of diflunisal- vs 1% of aspirin- and none of ibuprofen-treated patients).
Geoffroy P, Carteret E, Salagnac V, Kalis B, Zeitoun P. (1987). Therapie. (65 year old woman developed mild cholestatic jaundice 5 days after a 3 day course of diflunisal [bilirubin 2.6 mg/dL, AST 60 U/L and Alk P 1216 U/L, eosinophilia], resolving in several months: Case #1).
Cook DJ, Achong MR, Murphy FR. (1988). Three cases of diflunisal hypersensitivity. CMAJ. (Three patients with onset of fever, rash and eosinophilia [23-31%] or atypical lymphocytosis after 2-4 weeks of diflunisal therapy responding to oral and topical steroids; with bilirubin levels of normal, 0.9 and 4.9 mg/dL, ALT normal, 500 and 810 U/L, Alk P 185, 545 and 349 U/L).
Zimmerman HJ. (1990). Update of hepatotoxicity due to classes of drugs in common clinical use: non-steroid drugs, anti-inflammatory drugs, antibiotics, antihypertensives, and cardiac and psychotropic agents. Semin Liver Dis. (Extensive review article on liver injury due to NSAIDs; diflunisal said to cause cholestatic injury rarely).
Muller AF, Toghill PJ, Smith P. (1996). ‘Relapse’ of chronic active hepatitis--not always what it seems. Postgrad Med J. (Patient with typical autoimmune hepatitis treated with excellent response with steroids and then switched to azathioprine alone for 6 years; developed jaundice 1 month after starting diflunisal [bilirubin 2.9 mg/dL, ALT 668 U/L, Alk P 262 U/L], resolving upon stopping).
Björnsson E, Jerlstad P, Bergqvist A, Olsson R. (2005). Fulminant drug-induced hepatic failure leading to death or liver transplantation in Sweden. Scand J Gastroenterol. (Survey of all cases of drug induced liver injury with fatal outcome from Swedish Adverse Drug Reporting system from 1966-2002; among 103 cases, none were attributed to diflunisal).
Rostom A, Goldkind L, Laine L. (2005). Nonsteroidal anti-inflammatory drugs and hepatic toxicity: a systematic review of randomized controlled trials in arthritis patients. Clin Gastroenterol Hepatol. (Review of randomized clinical trials of NSAIDS for frequency of adverse events; ALT elevations above 3 fold ULN occurred in 0.43% of ibuprofen, 0.43% naproxen, 0.42% celecoxib, 1.8% rofecoxib, 3.55% diclofenac and 0.29% of placebo recipients; review deals largely with commonly used NSAIDs and does not mention diflunisal).
Lapeyre-Mestre M, de Castro AM, Bareille MP, et al. (2006). Non-steroidal anti-inflammatory drug-related hepatic damage in France and Spain: analysis from national spontaneous reporting systems. Fundam Clin Pharmacol. (Analysis of reports of liver injury from NSAIDs from France and Spain from 1982-2001; diflunisal is not listed in tables of adverse event reports from NSAIDs).
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J, Drug Induced Liver Injury Network (DILIN). (2008). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology. (Among 300 cases of drug induced liver disease in the US collected from 2004 to 2008, NSAIDs were implicated as a sole agent in 8 cases [4 diclofenac, 2 celecoxib, 1 meloxicam and 1 oxaprozin] and as one of several agents in 3 cases [1 diclofenac, 1 celecoxib, 1 ibuprofen]; diflunisal is not mentioned).
Reuben A, Koch DG, Lee WM, Acute Liver Failure Study Group. (2010). Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, of which 7 were due to NSAIDs, including 4 attributed to bromfenac, 2 to diclofenac and 1 to etodolac, but none to diflunisal).
Gulmez SE, Larrey D, Pageaux GP, Lignot S, Lassalle R, Jové J, Gatta A, et al. (2013). Transplantation for acute liver failure in patients exposed to NSAIDs or paracetamol (acetaminophen): the multinational case-population SALT study. Drug Saf. (Analysis of cases of idiopathic acute liver failure undergoing liver transplantation in 52 centers in Europe between 2005 and 2007, found 40 had been exposed to an NSAID, but none to diflunisal).
Lapeyre-Mestre M, Grolleau S, Montastruc JL, Adsociation Française des Centres Régionaux de Pharmacovigilance (CRPV). (2013). Adverse drug reactions associated with the use of NSAIDs: a case/noncase analysis of spontaneous reports from the French pharmacovigilance database 2002-2006. Fundam Clin Pharmacol. (Analysis of 42,389 spontaneous serious adverse event reports to the French Pharmacovigilance database on 8 NSAIDs between 2002 and 2006; liver adverse events were most frequent with nimesulide [0.15 per million daily doses] compared to diclofenac [0.09], ketoprofen [0.09] piroxicam [0.06], naproxen [0.04], meloxicam [0.03], and tenoxicam [0.03]; diflunisal is not discussed).
Berk JL, Suhr OB, Obici L, Sekijima Y, Zeldenrust SR, Yamashita T, Heneghan MA, et al., Diflunisal Trial Consortium. (2013). Repurposing diflunisal for familial amyloid polyneuropathy: a randomized clinical trial. JAMA. (Among 130 patients with familial amyloid polyneuropathy treated with diflunisal [250 mg] or placebo twice daily for 2 years, disease progression was less with diflunisal therapy and the overall rates of adverse events were similar with no mention of ALT elevations or hepatotoxicity and no liver related serious adverse events or deaths).
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. (2013). Incidence, Presentation and Outcomes in Patients with Drug-Induced Liver Injury in the General Population of Iceland. Gastroenterology. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, 6% of which were attributed to NSAIDS, but none to diflunisal).
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A, Chirino R, et al. (2014). Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol. (Systematic review of literature of drug induced liver injury from Latin American countries published between 1996 and 2012 identified 176 cases; while NSAIDs were the most frequent class of drugs implicated (n=62: 32%], no case was attributed to diflunisal).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al., United States Drug Induced Liver Injury Network. (2015). Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 20 cases [2%] were attributed to NSAIDs, but none to diflunisal).
Sekijima Y, Tojo K, Morita H, Koyama J, Ikeda S. (2015). Safety and efficacy of long-term diflunisal administration in hereditary transthyretin (ATTR) amyloidosis. Amyloid. (Among 40 Japanese patients with familial amyloidosis treated with diflunisal [500 mg daily] for up to 10 years, 3 patients stopped therapy because of side effects [thrombocytopenia and renal dysfunction which improved upon stopping]; no mention of ALT elevations or hepatotoxicity).

## OTHER REFERENCE LINKS

Recent References on Diflunisal: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=diflunisal/AE+AND+Human%5BMH%5D+AND+(jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))

Trials on Diflunisal: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=diflunisal)